# Adalimumab

## OVERVIEW

### Introduction

Adalimumab is a monoclonal antibody to human tumor necrosis factor (TNF) alpha which has potent antiinflammatory activity and is used in the therapy of severe rheumatoid arthritis and inflammatory bowel disease. Adalimumab has been linked to rare instances of idiosyncratic acute liver injury and is a potential cause of reactivation of hepatitis B.

### Background

Adalimumab (ay" da lim' ue mab) is a human recombinant monoclonal immunoglobulin G1 antibody to TNF alpha which binds avidly to serum and tissue-bound TNF, causing its inactivation and degradation. Inhibition of TNF alpha activity leads to modulation of the inflammatory and pain pathways activated by this cytokine which is found in elevated levels in several autoimmune and inflammatory conditions. Adalimumab was approved in the United States for use in rheumatoid arthritis in 2002, and subsequently its indications have been extended to ankylosing spondylitis, juvenile idiopathic (rheumatoid) arthritis, severe psoriasis and psoriatic arthritis, Crohn disease, ulcerative colitis, hidradenitis suppurative, and uveitis. It is used off-label for treatment of other autoimmune conditions including autoimmune hepatitis and immune-mediated drug-induced liver injury. Adalimumab is considered a disease modifying antirheumatic drug (DMARD), and has been shown to improve symptoms as well as joint and cartilage damage in the inflammatory arthritidies. Adalimumab is available in prefilled syringes or pens in various concentrations, most frequently 40 or 80 mg in 0.8 mL, generically and under the brand name of Humira. The typical maintenance dose of adalimumab in adults is 40 mg subcutaneously every other week. Common side effects include injection site reactions, headache, nausea, abdominal discomfort, diarrhea, skin rash and fever. Rare but potentially severe side effects include bone marrow suppression, demyelinating disorder, severe infections, lymphoma and other malignances, worsening of congestive heart failure, and hypersensitivity reactions. TNF alpha antagonists are also capable of causing immune suppression, resulting in reactivation of microbial infections including tuberculosis and hepatitis B.

### Hepatotoxicity

Adalimumab has been associated with a low rate of serum aminotransferase elevations during therapy, but these have been transient, mild and asymptomatic, and have rarely required dose modification. ALT levels above 3 times ULN have been reported in 1.0% to 3.5% of adalimumab recipients compared to 0.9% to 1.8% of controls. Rare instances of clinically apparent liver injury have been reported with adalimumab, resembling the hepatic injury that has been described with infliximab therapy. The onset of injury is usually within 3 months and the pattern of serum enzyme elevations hepatocellular. The injury was usually mild and anicteric and resolves promptly on stopping adalimumab. In some instances, however, the injury persists and resembles autoimmune hepatitis requiring corticosteroid therapy (Case 1). In reports with adequate follow up, most patients are able to discontinue immunosuppressive therapy. Liver injury from adalimumab appears to be less frequent and less severe than similar injury from infliximab. The reasons for these differences are not clear. Infliximab is a chimeric monoclonal antibody (mouse-human) while adalimumab is a fully human monoclonal antibody. While infliximab has been associated with cases of severe liver injury and death from liver failure, adalimumab has not. In many instances patients with infliximab induced liver injury have subsequently tolerated adalimumab therapy without recurrence and those with adalimumab induced liver injury have tolerated other TNF antagonists.

Like infliximab, adalimumab has been linked to cases of reactivation of hepatitis B. Reactivation typically occurs in patients who are inactive HBsAg carriers, with normal serum aminotransferase levels and no or only low levels of HBV DNA in serum. The immune suppression caused by the immunomodulatory agent leads to an increase in HBV replication and rise in serum HBV DNA levels. With stopping the immunosuppression (or between cycles of therapy), restoration of immune function leads to an acute immunological response to the heightened viral replication and an flare of hepatitis, that can be severe and can result in hepatic failure and death. Reactivation in patients with anti-HBc without HBsAg (serologic pattern of previous HBV infection) has been reported in rare patients treated with anti-TNF antagonists, and is more common after therapy with rituximab or bone marrow transplantation. The anti-TNF inhibitors have little or no effect on hepatitis C virus levels and have been used safely in patients with chronic hepatitis C.

Likelihood score: B (highly likely but rare cause of clinically apparent liver injury due to an autoimmune hepatitis-like injury or reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury due to adalimumab and other TNFα antagonists is not known, but is likely caused by immune modulation and induction of autoimmunity.

### Outcome and Management

Most published cases of hepatotoxicity of adalimumab have been mild and self-limiting, less frequent and less severe than that reported with infliximab. Patients who are to start adalimumab therapy should be screened for evidence of hepatitis B, and those with preexisting HBsAg in serum should be offered prophylaxis with an potent oral antiviral agent such as tenofovir or entecavir. Patients with anti-HBc without HBsAg in serum should receive antiviral therapy as prophylaxis or be monitored carefully with testing for HBV DNA in serum and started on antiviral therapy if HBV DNA arises, an early indicator of HBV reactivation.

Patients who develop an autoimmune hepatitis-like syndrome during adalimumab therapy may not recover promptly with stopping the TNF antagonist and may require corticosteroid therapy. In this event, the corticosteroid dose should be kept to a minimum to control the disease and, ultimately, attempts should be made to withdraw immunosuppression (or decrease to levels used to treat the underlying condition before administration of adalimumab).

Rechallenge with adalimumab can result in recurrence, while switching to other monoclonal anti-TNF such as infliximab, certolizumab, or golimumab may be safe from occurrence of liver injury but should be done with caution and careful monitoring. There does not appear to be cross reactivity in hepatic injury between adalimumab and etanercept, which is not a monoclonal antibody but rather a modified form of the TNFα receptor.

Drug Class: Antirheumatic Agents; Dermatologic Agents; Gastrointestinal Agents, Inflammatory Bowel Disease Agents

Other Drugs in the Subclass, Tumor Necrosis Factor Antagonists: Certolizumab, Etanercept, Golimumab, Infliximab

## CASE REPORTS

### Case 1. Hepatitis with jaundice due to adalimumab.(1)

A 44 year old woman with long standing Crohn disease was started on adalimumab in a dose of 40 mg subcutaneously every two weeks. She tolerated therapy well and her bowel symptoms improved. After 3 months of treatment she was found to have elevations in serum aminotransferase levels. Because of the success of therapy and her lack of symptoms, treatment was continued. After 11 months of treatment when she had the onset of fatigue, nausea and vomiting, abdominal pain, dark urine, and jaundice. Her past medical history included a cholecystectomy and two bowel resections for Crohn disease. She drank alcohol only occasionally and had no history of liver disease, risk factors for viral hepatitis, or drug allergies. Her other medications included amitriptyline for depression, omeprazole for gastrointestinal upset, and zolpidem for sleep. On examination she was jaundiced but had no rash, fever, or signs of liver failure. Serum bilirubin was 18.0 mg/dL, ALT 532 U/L, AST 932 U/L, Alk P 158 U/L, serum albumin 2.5 g/dL, and INR 3.2. Tests for hepatitis A, B and C were negative as was antinuclear antibody (ANA). A liver biopsy showed marked cholestasis and liver cell injury with ballooning degeneration without fibrosis. Imaging of the liver was unremarkable, and endoscopic retrograde cholangiopancreatography (ERCP) showed no biliary obstruction, or evidence of sclerosing cholangitis. Adalimumab had been stopped on admission and prednisone started. Her blood tests improved slowly and she was discharged after 4 weeks, still jaundiced but feeling better. When seen 2 months later liver tests were near normal, bilirubin having fallen to 0.7 mg/dL and INR improved at 1.2. Prednisone doses were tapered, and immunosuppressive therapy was discontinued 2 months later. In follow up all liver tests were normal except for intermittent mild elevations in alkaline phosphatase.

#### Key Points

Medication: | Adalimumab (40 mg subcutaneously every 2 weeks)
Pattern: | Hepatocellular (R=13.2)
Severity: | Severe, 4+ (jaundice, hospitalization, INR > 1.5)
Latency: | 3 months to onset of ALT elevations, 11 months to jaundice
Recovery: | 2 to 3 months
Other medications: | Chronically, amitriptyline, omeprazole, zolpidem

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 39 | 114 | 0.4 | Shortly before therapy
3 months | Pre | 165 | 188 | 0.6
8 months | Pre | 181 | 181 | 0.7
11 months | 0 days | 523 | 158 | 18.0 | Drug stopped, Pred started, INR 3.5
| 1 week | 218 | 172 | 12.6 | Liver biosy, INR 1.8
| 2 weeks | 153 | 132 | 13.4 | INR 1.6
| 3 weeks | 139 | 127 | 14.7 | ERCP
12 months | 1 month | 148 | 115 | 16.4 | Discharged, INR 1.4
| 3 months | 51 | 151 | 0.7 | INR 1.1
16 months | 4 months | 18 | 103 | 0.5
| 5 months | 35 | 121 | 0.5 | Prednisone stopped
| 8 months | 51 | 151 | 0.7
23 months | 12 months | 31 | 122 | 0.5 | INR 1.0
Normal values | | <45 | <120 | <1.2

#### Comment

A dramatic example of an autoimmune-like hepatitis arising in a patient with adalimumab induced liver injury. Serum aminotransferase elevations arose within 3 months of starting therapy but adalimumab was continued despite the ALT levels being above 3 times the ULN. The absence of symptoms and normal bilirubin are typical of the aminotransferase elevations that occur with anti-TNF therapy. Stopping therapy and restarting with careful monitoring might have been a more appropriate approach. The liver injury that arose after 11 months of treatment and eight months of abnormal liver tests was severe, with marked jaundice, prolongation of INR, and fall of serum albumin levels. Despite this, the patient recovered with little evidence of persistent liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Adalimumab – Humira®

DRUG CLASS

Antirheumatic Agents; Dermatologic Agents; Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Adalimumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Adalimumab | 331731-18-1 | Monoclonal antibody | Not available

## CITED REFERENCE

1 Ghabril M, Bonkovsky HL, Kum C, Davern T, Hayashi PH, Kleiner DE, Serrano J, et al; U.S. Drug-Induced Liver Injury Network. Liver injury from tumor necrosis factor-α antagonists: analysis of thirty-four cases. Clin Gastroenterol Hepatol 2013; 11: 558-64.23333219

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2026

Abbreviations Used: TNF, tumor necrosis factor alpha; anti-TNF, antibody to TNF; ANA, anti-nuclear antigen; dsDNA, double stranded DNA; HBV, hepatitis B virus; HBsAg, hepatitis B surface antigen; anti-HBs, antibody to HBsAg; anti-HBc, antibody to hepatitis B core antigen; HBeAg, hepatitis B e antigen; anti-HBe, antibody to HBeAg; HCV, hepatitis C virus, anti-HCV, antibody to HCV.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; no mention of monoclonal antibodies to tumor necrosis factor such as adalimumab).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents published in 2013; all of the monoclonal anti-TNF agents have been linked to cases of hepatoxicity ranging in severity from asymptomatic aminotransferase elevations to acute liver failure).
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-54. (Textbook of pharmacology and therapeutics).
Biancone L, Pavia M, De Vecchio Blanco G, D'Inca R, Castiglione F, De Nigris F, Doldo P, et al. Hepatitis B and C virus infection in Crohn's disease. Inflamm Bowel Dis 2001; 7: 287-94. (Among 332 Italian patients with Crohn disease, 7.4% had anti-HCV and 2.1% HBsAg compared to 5.1% and 2.1% of Italian controls; no clear change in hepatitis with therapy of Crohn disease in small numbers of cases studied retrospectively). 11720317
Day R. Adverse reactions to TNF-alpha inhibitors in rheumatoid arthritis. Lancet 2002; 359: 540-1. (Editorial on the severe side effects of long term anti-TNF therapy in rheumatoid arthritis focusing upon reactivation of tuberculosis, induction of a lupus-like syndrome and rare instances of cancer; no mention of hepatotoxicity). 11867103
Biancone L, Del Vecchio Blanco G, Pallone F, Castiglione F, Bresci G,Sturniolo G; Italian Group for the Study of the Colon and Rectum. Immunomodulatory drugs in Crohn's disease patients with hepatitis B or C virus infection. Gastroenterology 2002; 122: 593-4. (Further analysis of 4 patients with Crohn disease and hepatitis B who received immunomodulatory medications; no instances of reactivation). 11845808
Michel M, Duvoux C, Hezode C, Cherqui D. Fulminant hepatitis after infliximab in a patient with hepatitis B virus treated for an adult onset still's disease. J Rheumatol 2003; 30: 1624-5. (Patient with adult Still disease and HBsAg in serum [without HBeAg or HBV DNA] developed fever, rash and severe hepatitis after a second infusion of infliximab [direct bilirubin 14.6 mg/dL, ALT 30 times ULN], progressing to acute liver failure and liver transplant but without detectable HBV DNA; no testing for delta hepatitis). 12858469
Ostuni P, Botsios C, Punzi L, Sfriso P, Todesco S. Hepatitis B reactivation in a chronic hepatitis B surface antigen carrier with rheumatoid arthritis treated with infliximab and low dose methotrexate. Ann Rheum Dis 2003; 62: 686-7. (59 year old man with rheumatoid arthritis and HBsAg in serum developed hepatitis 18 months after starting infliximab [bilirubin 1.3 mg/dL, ALT 573 U/L] with presence of IgM anti-HBc and increase in serum HBV DNA polymerase activity; resolution in 2 months). 12810441
Peterson JR, Hsu FC, Simkin PA, Wener MH. Effect of tumour necrosis factor alpha antagonists on serum transaminases and viraemia in patients with rheumatoid arthritis and chronic hepatitis C infection. Ann Rheum Dis 2003; 62: 1078-82. (Monitoring of 24 patients with both rheumatoid arthritis and hepatitis C found no overall changes in ALT, AST, Alk P or HCV RNA levels during therapy with etanercept or infliximab over a period of 2-34 months). 14583571
Furst DE, Schiff MH, Fleischmann RM, Strand V, Birbara CA, Compagnone D, Fischkoff SA, et al. Adalimumab, a fully human anti tumor necrosis factor-alpha monoclonal antibody, and concomitant standard antirheumatic therapy for the treatment of rheumatoid arthritis: results of STAR (Safety Trial of Adalimumab in Rheumatoid Arthritis). J Rheumatol 2003; 30: 2563-71. (Controlled trial of 24 weeks of adalimumab vs placebo in 636 patients with rheumatoid arthritis; adverse events were similar between the two groups with no differences in mean ALT or AST levels; adalimumab group had higher rates of de novo autoantibody formation [ANA 27% vs 15%, anti-DNA 13% vs 1%]). 14719195
Weinblatt ME, Keystone EC, Furst DE, Moreland LW, Weisman MH, Birbara CA, Teoh LA, et al. Adalimumab, a fully human anti-tumor necrosis factor alpha monoclonal antibody, for the treatment of rheumatoid arthritis in patients taking concomitant methotrexate: the ARMADA trial. Arthritis Rheum 2003; 48: 35-45. (Controlled trial of 24 weeks of adalimumab vs placebo in 271 patients with rheumatoid arthritis found no significant changes in serum ALT levels and no instance of clinically apparent liver injury). 12528101
Khanna D, McMahon M, Furst DE. Safety of tumour necrosis factor-alpha antagonists. Drug Saf 2004; 27: 307-24. (Review of safety of anti-TNF agents based on literature and FDA reports found no evidence of worsening of hepatitis C during therapy, but there was a chance of reactivation of hepatitis B, at least by infliximab; no discussion of hepatotoxicity). 15061685
Parke FA, Reveille JD. Anti-tumor necrosis factor agents for rheumatoid arthritis in the setting of chronic hepatitis C infection. Arthritis Rheum 2004; 51: 800-4. (Among 5 patients with rheumatoid arthritis and HCV infection who were treated with etanercept or infliximab for 8-49 months, none had worsening of serum ALT levels and HCV RNA levels were stable or decreased). 15478165
Calabrese LH, Zein N, Vassilopoulos D. Safety of antitumour necrosis factor(anti-TNF) therapy in patients with chronic viral infections: hepatitis C, hepatitis B, and HIV infection. Ann Rheum Dis 2004; 63 Suppl 2: ii18-ii24. (Review of the safety and complications of anti-TNF therapy in patients with concurrent hepatitis B or C or HIV infection). 15479865
Eriksson C, Engstrand S, Sundqvist KG, Rantapää-Dahlqvist S. Autoantibody formation in patients with rheumatoid arthritis treated with anti-TNF alpha. Ann Rheum Dis 2005; 64: 403-7. (Among 53 patients with rheumatoid arthritis treated with infliximab, ANA titers frequently increased and a proportion of patients developed anti-dsDNA while symptoms improved and rheumatoid factor titers fell). 15297281
Mizuta M, Schuster MG. Cytomegalovirus hepatitis associated with use of anti-tumor necrosis factor-alpha antibody. Clin Infect Dis 2005; 40: 1071-2. (45 year old woman with Crohn disease developed fever and abnormal liver tests [ALT 282 U/L, Alk P 845 U/L, bilirubin 1.1 mg/dL], and liver biopsy showing changes of cytomegalovirus hepatitis, resolving rapidly with ganciclovir therapy). 15825012
Scheinfeld N. Adalimumab: a review of side effects. Expert Opin Drug Saf 2005; 4: 637-41. (Review of side effects of adalimumab therapy mentions that it can induce a lupus-like syndrome [~0.1%] and minor ALT elevations). 16011443
Roux CH, Brocq O, Breuil V, Albert C, Euller-Ziegler L. Safety of anti-TNF-alpha therapy in rheumatoid arthritis and spondyloarthropathies with concurrent B or C chronic hepatitis. Rheumatology (Oxford) 2006; 45: 1294-7. (Retrospective analysis of 6 patients with chronic hepatitis and inflammatory arthritis treated with anti-TNF agents for 3-39 months, none had risen in ALT or viral levels during therapy, but 3 with hepatitis B were also on lamivudine). 16603583
Nathan DM, Angus PW, Gibson PR. Hepatitis B and C virus infections and anti-tumor necrosis factor-. therapy: guidelines for clinical approach. J Gastro Hepatol 2006; 31: 1366-71. (Review and proposed guidelines for use of anti-TNF therapy in patients with underlying chronic viral hepatitis; recommended screening for HBV and HCV, careful monitoring during therapy and prophylaxis or early intervention with lamivudine in HBsAg-positive patients). 16911678
Calabrese LH, Zein NN, Vassilopoulos D. Hepatitis B virus(HBV) reactivation with immunosuppressive therapy in rheumatic diseases: assessment and preventive strategies. Ann Rheum Dis 2006; 65: 983-9. (Review of the problem of reactivation of hepatitis B in patients with rheumatic diseases treated with immunosuppressive agents, with recommendations on prevention). 16627542
Vassilopoulos D, Calabrese LH. Risks of immunosuppressive therapies including biologic agents in patients with rheumatic diseases and co-existing chronic viral infections. Curr Opin Rheumatol 2007; 19: 619-25. (Review of use of anti-TNF agents in patients with chronic hepatitis B, C and HIV infection). 17917544
Sakellariou GT, Chatzigiannis I. Long-term anti-TNFalpha therapy for ankylosing spondylitis in two patients with chronic HBV infection. Clin Rheumatol 2007; 26: 950-2. (Two patients with ankylosing spondylitis and inactive HBsAg carrier state who were treated with infliximab; 43 year old man developed reactivation after 14 weeks [ALT 49 U/L, HBV DNA positive] and was successfully treated with lamivudine; 41 year old man had ALT elevations [85 U/L], but no reactivation even when later switched to etanercept). 16865308
Ferri C, Ferraccioli G, Ferrari D, Galeazzi M, Lapadula G, Montecucco C, Triolo G, et al; GISEA Group. Safety of anti-tumor necrosis factor-alpha therapy in patients with rheumatoid arthritis and chronic hepatitis C virus infection. J Rheumatol 2008; 35: 1944-9. (Prospective study in 31 patients with rheumatoid arthritis and hepatitis C treated with anti-TNF agents for 7-44 months [adalimumab 3, etanercept 17; infliximab 11]; mean levels of HCV RNA and ALT did not change; fluctuations occurred in a few patients, but no correlation found between changes in viral RNA and ALT levels). 18688917
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, etanercept was implicated in 3 cases, but neither infliximab nor adalimumab were linked to any). 18955056
Levämpi T, Korpela M, Vuolteenaho K, Moilanen E. Etanercept and adalimumab treatment in patients with rheumatoid arthritis and spondyloarthropathies in clinical practice: adverse events and other reasons leading to discontinuation of the treatment. Rheumatol Int 2008; 28: 261-9. (Among 17 patients with inflammatory arthritidies who stopped anti-TNF therapy because of side effects, none were for hepatotoxicity). 17846778
Domm S, Cinatl J, Mrowietz U. The impact of treatment with tumour necrosis factor-alpha antagonists on the course of chronic viral infections: a review of the literature. Br J Dermatol 2008; 159: 1217-28. (Review of literature on efficacy and safety of TNF antagonists in patients with chronic hepatitis B and C recommends screening and monitoring). 18945310
Zingarelli S, Airò Frassi M, Bazzani C, Scarsi M, Puoti M. Prophylaxis and therapy of HBV infection in 20 patients treated with disease modifying antirheumatic drugs or with biological agents for rheumatic diseases. Reumatismo 2008; 60: 22-7. (Retrospective analysis of results of treating 20 patients with rheumatic conditions and serum HBsAg using immunosuppressive agents, all tolerating therapy well, and reactivation prevented by prophylactic antiviral therapy). 18432322
Burmester GR, Mease P, Dijkmans BA, Gordon K, Lovell D, Panaccione R, Perez J, et al. Adalimumab safety and mortality rates from global clinical trials of six immune-mediated inflammatory diseases. Ann Rheum Dis 2009; 68: 1863-9. (Among 19,041 patients treated with adalimumab in 36 clinical trials, serious infections occurred in 1-5 patients per year; no discussion of hepatotoxicity or ALT levels). 19147611
Zingarelli S, Frassi M, Bazzani C, Scarsi M, Puoti M, Airò P. Use of tumor necrosis factor-alpha-blocking agents in hepatitis B virus-positive patients: reports of 3 cases and review of the literature. J Rheumatol 2009; 36: 1188-94. (3 patients with rheumatoid arthritis and HBsAg in serum treated with etanercept, infliximab or adalimumab for up to 3 years; 2 with lamivudine prophylaxis did not develop reactivation, 1 without prophylaxis developed mild reactivation at 6 months and was successfully treated with lamivudine; review of literature found reactivation to occur in 12 of 16 patients not given prophylaxis, but only mild rise in HBV DNA in 1 of 7 on lamivudine). 19447932
Robinson H, Walker-Bone K. Anti-TNF-alpha therapy for rheumatoid arthritis among patients with chronic hepatitis B infection. Rheumatology (Oxford) 2009; 48: 448-50. (63 year old woman with rheumatoid arthritis and inactive hepatitis B treated with various combinations of etanercept, adalimumab, prednisone and methotrexate had no evidence of significant reactivation after 2 years of therapy; on review of literature, authors conclude that prophylaxis is not usually necessary). 19223285
Caramaschi P, Bambara LM, Pieropan S, Tinazzi I, Volpe A, Biasi D. Anti-TNFalpha blockers, autoantibodies and autoimmune diseases. Joint Bone Spine 2009; 76: 333-42. (Review of frequency of appearance of autoantibodies and autoimmune conditions during anti-TNF therapy). 19539516
Li S, Kaur PP, Chan V, Berney S. Use of tumor necrosis factor-alpha(TNF-alpha) antagonists infliximab, etanercept, and adalimumab in patients with concurrent rheumatoid arthritis and hepatitis B or hepatitis C: a retrospective record review of 11 patients. Clin Rheumatol 2009; 28: 787-91. (Retrospective analysis of 11 patients with rheumatoid arthritis and either hepatitis B [n=3] or C [n=8] during 3 to 60 months anti-TNF therapy, 3 had transient minimal ALT elevations [peak levels 51, 73 and 51 U/L] without symptoms or jaundice). 19291350
Massarotti M, Marasini B. Successful treatment with etanercept of a patient with psoriatic arthritis after adalimumab-related hepatotoxicity. Int J Immunopathol Pharmacol 2009; 22: 547-9. (46 year old man with psoriatic arthritis developed rising ALT levels [19 to 96 to 252 U/L] 2 months after starting adalimumab, with resolution within 2 months of stopping and no recurrence after switching to etanercept). 19505409
Wetter DA, Davis MD. Lupus-like syndrome attributable to anti-tumor necrosis factor alpha therapy in 14 patients during an 8-year period at Mayo Clinic. Mayo Clin Proc 2009; 84: 979-84. (Retrospective analysis of 14 cases of lupus-like syndrome arising during anti-TNF therapy [13 infliximab, 1 adalimumab] over 8 year period; all were ANA positive and most had anti-dsDNA, onset with rash, serositis, fatigue, arthralgias, oral ulcers, but no renal or CNS involvement, all improved on stopping and tolerated other, but not the same anti-TNF agent; no hepatic manifestations mentioned). 19880688
Charpin C, Guis S, Colson P, Borentain P, Mattéi JP, Alcaraz P, Balandraud N, et al. Safety of TNF-blocking agents in rheumatic patients with serology suggesting past hepatitis B state: results from a cohort of 21 patients. Arthritis Res Ther 2009; 11: R179. (21 patients with rheumatic conditions who had anti-HBc without HBsAg in serum and were monitored during 7-56 months of therapy with infliximab [4], etanercept [14] or adalimumab [2]; anti-HBs titers decreased minimally, and no patient developed HBV DNA or HBsAg or features of reactivation). 19941642
Giannitti C, Benucci M, Caporali R, Manganelli S, Bellisai F, Sebastiani GD, Galeazzi M. Efficacy and safety of anti-TNF-alpha therapy combined with cyclosporine A in patients with rheumatoid arthritis and concomitant hepatitis C virus infection. Int J Immunopathol Pharmacol 2009; 22: 543-6. (7 patients with rheumatoid arthritis and chronic hepatitis C were treated with cyclosporine and either etanercept or adalimumab and had clinical improvements with no worsening of liver disease, but instead mild decreases in ALT [38 to 26 U/L] and HCV RNA levels [7.1 to 2.3 million IU/mL]). 19505408
Kaiser T, Moessner J, Patel K, McHutchison JG, Tillmann HL. Life threatening liver disease during treatment with monoclonal antibodies. BMJ 2009; 338: b508. (66 year old man with psoriasis was treated with efalizumab [anti-CD11a] and then adalimumab [anti-TNF] and 11 days later developed jaundice and severe hepatitis [bilirubin 9.1 rising to 52 mg/dL, ALT 549 U/L, Alk P 131 U/L], with HBsAg being detected and slow, but eventual recovery). 19224957
Shale MJ, Seow CH, Coffin CS, Kaplan GG, Panaccione R, Ghosh S. Review article: chronic viral infection in the anti-tumour necrosis factor therapy era in inflammatory bowel disease. Aliment Pharmacol Ther 2010; 31: 20-34. (Extensive review of literature on effects of anti-TNF therapies on underlying chronic hepatitis B and C; among 28 HBV-infected patients, reactivation was common in those not on antiviral therapy, more frequent with monoclonal antibodies than etanercept; among 110 HCV-infected patients, little evidence of worsening of disease and in some instances a decrease in HCV RNA levels). 19681818
Sokolove J, Strand V, Greenberg JD, Curtis JR, Kavanaugh A, Kremer JM, Anofrei A, et al.; CORRONA Investigators. Risk of elevated liver enzymes associated with TNF inhibitor utilisation in patients with rheumatoid arthritis. Ann Rheum Dis 2010; 69: 1612-7. (Retrospective analysis of ALT and AST elevations among 6861 patients with rheumatoid arthritis enrolled in a North American database receiving TNF inhibitors followed for an average of 1.5 years with ~1.7 determinations yearly; any elevation of ALT or AST occurred in 5.4% of visits, >2 times ULN in 0.6%, >5 times ULN in 0.1%; rates slightly higher for those on infliximab alone or combined with methotrexate and leflunomide). 20448284
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Review of the hepatotoxicity of drugs used to treat inflammatory bowel disease focusing upon sulfasalazine, thiopurines, TNF inhibitors, and methotrexate). 20926880
Cravo M, Silva R, Serrano M. Autoimmune hepatitis induced by infliximab in a patient with Crohn's disease with no relapse after switching to adalimumab. BioDrugs 2010; 24 Suppl 1:25-7. (38 year old woman with Crohn disease, was on and off infliximab for 8 years, developed abnormal liver tests [bilirubin normal, ALT 191 U/L, ANA 1:640], responding to prednisolone and azathioprine within 12 weeks and later treated with adalimumab without worsening of liver disease, but while on long term azathioprine [50 mg/day]). 21175232
Katsanos KH, Tsianos VE, Zois CD, Zioga H, Vagias I, Zervou E, Christodoulou DK, et al.; Northwest Greece IBD Study Group. Inflammatory bowel disease and hepatitis B and C in Western Balkans: a referral centre study and review of the literature. J Crohns Colitis 2010; 4: 450-65. (Among 482 patients with inflammatory bowel disease, 11 had HBV and 4 HCV, antiviral therapy for which did not worsen the underlying bowel disease). 21122543
Hagel S, Bruns T, Theis B, Herrmann A, Stallmach A. Subacute liver failure induced by adalimumab. Int J Clin Pharmacol Ther. 2011;49:38-40.21176723
(44 year old woman with psoriasis developed jaundice 4 months after starting adalimumab that progressed to subacute liver failure [peak bilirubin 3.5 mg/dL, ALT 15 times ULN, resolving slowly but completely after discontinuation) .
Fotiadou C, Lazaridou E, Ioannides D. Safety of anti-tumour necrosis factor-α agents in psoriasis patients who were chronic hepatitis B carriers: a retrospective report of seven patients and brief review of the literature. J Eur Acad Dermatol Venereol 2011; 25: 471-4. (Seven patients with psoriasis and HBsAg carrier state were treated with adalimumab, etanercept or infliximab for 6-24 months with lamivudine prophylaxis and none suffered reactivation, HBV DNA being undetectable or present at low levels). 20561122
Carroll MB, Forgione MA. Use of tumor necrosis factor alpha inhibitors in hepatitis B surface antigen-positive patients: a literature review and potential mechanisms of action. Clin Rheumatol 2010; 29: 1021-9. (Review of literature on anti-TNF therapy in patients with hepatitis B identified 35 cases, 7 cases of reactivation occurred, including 7 of 17 on infliximab, but none of 12 on etanercept or 6 on adalimumab; 18 received lamivudine, but only 7 as prophylaxis). 20556450
Caporali R, Bobbio-Pallavicini F, Atzeni F, Sakellariou G, Caprioli M, Montecucco C, Sarzi-Puttini P. Safety of tumor necrosis factor alpha blockers in hepatitis B virus occult carriers (hepatitis B surface antigen negative/anti-hepatitis B core antigen positive) with rheumatic diseases. Arthritis Care Res (Hoboken) 2010; 62: 749-54. (Among 732 patients treated with anti-TNF agents, 5 had HBsAg and were given prophylaxis with lamivudine and 67 had anti-HBc without HBsAg [25 on infliximab, 23 etanercept, 19 adalimumab], none of whom developed HBsAg or reactivation during an average follow up of 3.5 years). 20535784
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to a TNF antagonist). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children, included 60 due to infliximab making it rank 18th in frequency; no other TNF antagonist had more than 30 cases). 21039766
Vassilopoulos D, Apostolopoulou A, Hadziyannis E, Papatheodoridis GV, Manolakopoulos S, Koskinas J, Manesis EK, et al. Long-term safety of anti-TNF treatment in patients with rheumatic diseases and chronic or resolved hepatitis B virus infection. Ann Rheum Dis 2010; 69: 1352-5. (Among 131 patients with rheumatic conditions treated with anti-TNF, 14 had HBsAg [all were given prophylactic anti-HBV therapy], 19 had anti-HBs alone [from vaccination] and 19 anti-HBc [from previous infection]; during an average of 2 years of therapy, one patient with HBsAg on lamivudine developed rising titers of HBV DNA and was successfully treated with tenofovir, while all others had no change in serologic status or ALT levels). 20472596
Kim YJ, Bae SC, Sung YK, Kim TH, Jun JB, Yoo DH, Kim TY, et al. Possible reactivation of potential hepatitis B virus occult infection by tumor necrosis factor-alpha blocker in the treatment of rheumatic diseases. J Rheumatol 2010; 37: 346-50. (Among 266 Korean patients with rheumatic conditions receiving anti-TNF therapy, 8 had HBsAg and 88 anti-HBc without HBsAg; 2 of the 8 HBsAg-positive patients developed reactivation and ALT elevations were more common in the anti-HBc-positive group [16%] than the antibody-negative group [6%], but reactivation was not demonstrated and clinical features were not given). 20008922
Féau S, Causse X, Corondan A, Michenet P, Autret-Leca E. [Acute drug-induced hepatitis during adalimumab and ibuprofen treatment]. Gastroenterol Clin Biol 2010; 34: 420-2. French. PMID: 20494537 (61 year old man with rheumatoid arthritis on adalimumab for 15 months and occasional ibuprofen developed hepatitis [bilirubin 2.9 mg/dL, ALT 2491 U/L, Alk P 292 U/L, ANA negative], resolving within 4 months of stopping medications and increasing prednisone dose)
Adar T, Mizrahi M, Pappo O, Scheiman-Elazary A, Shibolet O. Adalimumab-induced autoimmune hepatitis. J Clin Gastroenterol 2010; 44: e20-2. (36 year old woman with psoriasis and Crohn disease developed nausea after starting adalimumab, and after 3 months liver tests were found to be abnormal [bilirubin 0.7 mg/dL, ALT 1265 U/L, Alk P 102 U/L, ANA 1:80], resolving within 2 months of stopping therapy and starting prednisone and azathioprine). 19593165
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, Lindor K. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. PubMed Citation (Among 261 cases of autoimmune hepatitis seen at the Mayo Clinic between 1997 and 2007, 24 were attributed to drugs, 11 to minocycline, 11 to nitrofurantoin, but none due to anti-TNF agents; all responded to corticosteroid therapy and did not relapse when withdrawn). 20512992
Stine JG, Bass M, Ibrahim D, Khokhar OS, Lewis JH. Dermatologists' awareness of and screening practices for hepatitis B virus infection before initiating tumor necrosis factor-α inhibitor therapy. South Med J 2011; 104: 781-8. (Results of email questionnaire sent to 1,000 US dermatologists found that 52% of 62 respondents were aware of guidelines for screening for HBV before using anti-TNF agents, but only 42% routinely screened patients and none of the 62 had ever seen a case of HBV reactivation). 22089354
Pérez-Alvarez R, Díaz-Lagares C, García-Hernández F, Lopez-Roses L, Brito-Zerón P, Pérez-de-Lis M, Retamozo S, et al.; BIOGEAS Study Group. Hepatitis B virus (HBV) reactivation in patients receiving tumor necrosis factor (TNF)-targeted therapy: analysis of 257 cases. Medicine (Baltimore) 2011; 90: 359-71. (Systematic review of literature identified 257 patients with preexisting HBV markers who received anti-TNF therapy, reactivation occurred in 39% of 89 patients with HBsAg [5 had acute liver failure and 4 died], but only 5% of 168 with anti-HBc without HBsAg [1 died]; lamivudine prophylaxis decreased, but did not eliminate reactivation [62% vs 23% in HBsAg carriers]). 22033451
Brunasso AM, Puntoni M, Gulia A, Massone C. Safety of anti-tumour necrosis factor agents in patients with chronic hepatitis C infection: a systematic review. Rheumatology (Oxford) 2011; 50: 1700-11. (Systematic review of literature identified 153 patients with chronic hepatitis C treated with anti-TNF agents, mostly etanercept, with only 1 with definite worsening of disease on treatment). 21690185
Goldfeld DA, Verna EC, Lefkowitch J, Swaminath A. Infliximab-induced autoimmune hepatitis with successful switch to adalimumab in a patient with Crohn's disease: the index case. Dig Dis Sci 2011; 56: 3386-8. (58 year old woman with Crohn disease developed ALT elevations [6 times ULN] 6 months after starting infliximab [peak ALT 210 U/L, ANA 1:2560], resolving within 4 months of stopping and later tolerating adalimumab without recurrence). 21597977
Manzano-Alonso ML, Castellano-Tortajada G. Reactivation of hepatitis B virus infection after cytotoxic chemotherapy or immunosuppressive therapy. World J Gastroenterol 2011; 17: 1531-7. (Review of reactivation of hepatitis B with chemotherapy or immune suppression discusses 11 cases attributed to infliximab and 7 to etanercept). 21472116
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. (Review of liver injury due to antirheumatic drugs discusses ALT elevations caused by anti-TNF agents and autoimmune hepatitis due to infliximab). 21263458
Abramson A, Menter A, Perrillo R. Psoriasis, hepatitis B, and the tumor necrosis factor-alpha inhibitory agents: a review and recommendations for management. J Am Acad Dermatol 2012; 67: 1349-61. (Systematic review of the literature on risk of reactivation of hepatitis B in patients with psoriasis on anti-TNF therapy found considerable risk in patients with HBsAg who do not receive antiviral prophylaxis, but no reported cases of reactivation among patients with anti-HBc without HBsAg). 22727462
Titos Arcos JC, Hallal H, Robles M, Andrade RJ. Recurrent hepatotoxicity associated with etanercept and adalimumab but not with infliximab in a patient with rheumatoid arthritis. Rev Esp Enferm Dig 2012; 104: 282-4. (47 year old woman with rheumatoid arthritis was found to have abnormal liver tests 2 years after starting etanercept [ALT 13 times ULN, ANA positive], resolving within 80 days of stopping and recurring 2 months after starting adalimumab [ALT 4 times ULN], but not after switching to infliximab). 22662786
Viganò M, Degasperi E, Aghemo A, Lampertico P, Colombo M. Anti-TNF drugs in patients with hepatitis B or C virus infection: safety and clinical management. Expert Opin Biol Ther 2012; 12: 193-207. (Systematic review of effects of anti-TNF agents on hepatitis B and C, concluding that patients with hepatitis B should receive antiviral prophylaxis whereas those with hepatitis C need not). 22188392
Grasland A, Sterpu R, Boussoukaya S, Mahe I. Autoimmune hepatitis induced by adalimumab with successful switch to abatacept. Eur J Clin Pharmacol 2012; 68: 895-8. d PMID: 22205272 (35 year old woman with rheumatoid arthritis developed liver enzyme elevations 2 months after switching from etanercept to adalimumab [bilirubin normal, ALT 266 U/L, Alk P normal, ANA 1:80, SMA 1:320], resolving after stopping and increasing dose of prednisone; later tolerating abatacept [anti-CTLA4]).
Di Minno MN, Iervolino S, Peluso R, Russolillo A, Lupoli R, Scarpa R, Di Minno G, et al; CaRRDS Study Group. Hepatic steatosis and disease activity in subjects with psoriatic arthritis receiving tumor necrosis factor-α blockers. J Rheumatol 2012; 39: 1042-6. (48 patients with psoriatic arthritis and hepatic steatosis by ultrasound were monitored prospectively during anti-TNF treatment; steatosis increased in 47% of anti-TNF treated patients, but only 19% of controls). 22422493
Anelli MG, Scioscia C, Grattagliano I, Lapadula G. Old and new antirheumatic drugs and the risk of hepatotoxicity. Ther Drug Monit 2012; 34: 622-8. (Review of hepatotoxicity of antirheumatic agents). 23128910
Park SH, Yang SK, Lim YS, Shim JH, Yang DH, Jung KW, et al. Clinical courses of chronic hepatitis B virus infection and inflammatory bowel disease in patients with both diseases. Inflamm Bowel Dis 2012; 18: 2004-10. (Among 4153 Korean patients with inflammatory bowel disease, 134 [3.2%] had HBsAg but only 23 [17%] had abnormal liver tests, but mortality rate was higher in HBsAg-positive than -negative group [5.2% vs 0.4%], with 2 deaths from liver failure and 3 liver cancer). 22337144
Efe C. Drug induced autoimmune hepatitis and TNF-α blocking agents: is there a real relationship? Autoimmun Rev 2013; 12: 337-9. (Review of evidence that anti-TNF agents induced autoimmune hepatitis commenting on the rarity of clinically apparent liver injury and the underlying autoimmune diathesis of most treated patients). 22841985
Lin MV, Blonski W, Buchner AM, Reddy KR, Lichtenstein GR. The influence of anti-TNF therapy on the course of chronic hepatitis C virus infection in patients with inflammatory bowel disease. Dig Dis Sci 2013; 58: 1149-56. (Among 4274 patients with inflammatory bowel disease and 3523 with hepatitis C seen in a single health care system, 37 had both, 5 of whom received anti-TNF, none of whom developed flares of hepatitis C during therapy). 23179145
Ghabril M, Bonkovsky HL, Kum C, Davern T, Hayashi PH, Kleiner DE, Serrano J, et al; U.S. Drug-Induced Liver Injury Network. Liver injury from tumor necrosis factor-α antagonists: analysis of thirty-four cases. Clin Gastroenterol Hepatol 2013; 11: 558-64. (Description of 6 cases of liver injury attributed to anti-TNF agents [3 infliximab, 2 etanercept, 1 adalimumab] in 5 women and 1 man, mean age 32 years with time to onset of 2 to 52 weeks; 3 were ANA positive and 5 were treated with prednisone; all resolved; review of 28 cases described in the literature, most due to infliximab [26], one resulting in liver transplant). 23333219
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 4 [1 with jaundice] attributed to infliximab [ranking 3rd], for an estimated incidence of 1 per 148 persons exposed but none attributed to adalimumab). 23419359
Pompili M, Biolato M, Miele L, Grieco A. Tumor necrosis factor-α inhibitors and chronic hepatitis C: a comprehensive literature review. World J Gastroenterol 2013; 19: 7867-73. (Systematic review of the literature on the safety of TNF antagonists in patients with chronic HCV infection identified reports on a total of 216 patients, and only rare instances of worsening of liver disease during therapy). 24307780
Kim E, Bressler B, Schaeffer DF, Yoshida EM. Severe cholestasis due to adalimumab in a Crohn's disease patient. World J Hepatol 2013; 5: 592-5. (39 year old woman with Crohn disease developed jaundice and itching 7 months after adding adalimumab to azathioprine [bilirubin 9.8 mg/dL, ALT 15 U/L, Alk P 183 U/L, ANA negative], biopsy showing bland cholestasis and injury, resolving 10 weeks after stopping both drugs, but later tolerating azathioprine alone). 24179620
Italian Group for the Study of Inflammatory Bowel Disease, Armuzzi A, Biancone L, Daperno M, Coli A, Pugliese D, Annese V, Aratari A, et al. Adalimumab in active ulcerative colitis: a "real-life" observational study. Dig Liver Dis 2013; 45: 738-43. (Retrospective analysis of the efficacy and safety of adalimumab in ulcerative colitis from 22 Italian centers identified 88 patients; side effects were reported in 12 patents, but none were due to liver injury). 23683530
Carvalheiro J, Mendes S, Sofia C. Infliximab induced liver injury in Crohn's disease: A challenging diagnosis. J Crohns Colitis 2013 Nov 29. [Epub ahead of print] (24 year old man with Crohn disease developed serum enzyme elevations after a 2nd infusion of infliximab, which increased over the next 5 months [bilirubin not given, peak ALT 211 U/L, Alk P 388 U/L] and then fell back into the normal range 8 months after switching to adalimumab). 24291019
Rossi RE, Parisi I, Despott EJ, Burroughs AK, O'Beirne J, Conte D, Hamilton MI, Murray CD. Anti-tumour necrosis factor agent and liver injury: literature review, recommendations for management. World J Gastroenterol 2014; 20: 17352-9. (Review of the literature on liver injury during anti-TNF therapy stresses that most ALT elevations are mild-to-moderate and self-limiting even with continuation of therapy). 25516646
Carvalheiro J, Mendes S, Sofia C. Infliximab induced liver injury in Crohn's disease: a challenging diagnosis. J Crohns Colitis 2014; 8: 436-7. (24 year old man with Crohn disease developed liver enzyme elevations after a second infusion of infliximab [bilirubin not given, ALT 211 U/L, Alk P 388 U/L], biopsy showing chronic hepatitis and cholestasis, improving slowly after switching to adalimumab). 24291019
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; none were attributed to a TNF antagonist). 24552865
Shelton E, Chaudrey K, Sauk J, Khalili H, Masia R, Nguyen DD, Yajnik V, et al. New onset idiosyncratic liver enzyme elevations with biological therapy in inflammatory bowel disease. Aliment Pharmacol Ther 2015; 41: 972-9. (Among 1753 patients with inflammatory bowel disease receiving anti-TNF therapies between 2009 and 2013, 102 developed ALT elevations but half could be attributed to another cause and the 48 attributed to infliximab [45 of 1170: 3%] or adalimumab [3 of 575: 0.5%], 34 patients [71%] recovering despite continuation of therapy, 4 stopping therapy and 10 switching to an alternative agent without suffering recurrence). 25756190
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab). 25412906
Capkin E, Karkucak M, Cosar AM, Ak E, Karaca A, Gokmen F, Budak BS, Tosun M. Treatment of ankylosing spondylitis with TNF inhibitors does not have adverse effect on results of liver function tests: a longitudinal study. Int J Rheum Dis 2015; 18: 548-52. (Among 94 patients with ankylosing spondylitis treated with infliximab [n=28], adalimumab [n=32] or etanercept [n=34], there was no change in mean ALT levels after 3 and 6 months of therapy). 24612551
Petríková J, Jarčuška P, Svajdler M, Pella D, Macejová Z. Autoimmune hepatitis triggered by adalimumab and allergic reactions after various anti-TNFα therapy agents in a patient with rheumatoid arthritis. Isr Med Assoc J 2015; 17: 256-8. (33 year old woman with rheumatoid arthritis developed fatigue after 3 doses of adalimumab [bilirubin not given, ALT 888 U/L, Alk P 348 U/L, ANA positive], biopsy showing interface hepatitis, resolving with prednisolone; later having allergic reactions to etanercept and certolizumab, but responding to anakinra). 26040057
Shelton E, Chaudrey K, Sauk J, Khalili H, Masia R, Nguyen DD, Yajnik V, Ananthakrishnan AN. New onset idiosyncratic liver enzyme elevations with biological therapy in inflammatory bowel disease. Aliment Pharmacol Ther 2015; 41: 972-9. (Among 1753 patients with inflammatory bowel disease treated with anti-TNF agents, 102 [6%] developed ALT elevations, but half could be attributed to other causes; among 48 with suspected anti-TNF injury [45 infliximab, 3 adalimumab], 34 resolved spontaneously and were able to continue therapy, 10 switched to another agent without recurrence, 4 were treated with corticosteroids). 25756190
Rodrigues S, Lopes S, Magro F, Cardoso H, Horta e Vale AM, Marques M, Mariz E, et al. Autoimmune hepatitis and anti-tumor necrosis factor alpha therapy: A single center report of 8 cases. World J Gastroenterol 2015; 21: 7584-8. (Among more than 600 patients treated with anti-TNF agents over a 7 year period, 8 developed autoimmune hepatitis [7 on infliximab, 1 adalimumab]; 3 men, 5 women, most with ANA, 2 symptomatic, no mention of jaundice; all responding to corticosteroids, 2 requiring long term therapy). 26140007
Björnsson ES, Gunnarsson BI, Gröndal G, Jonasson JG, Einarsdottir R, Ludviksson BR, Gudbjörnsson B, Olafsson S. Risk of drug-induced liver injury from tumor necrosis factor antagonists. Clin Gastroenterol Hepatol 2015; 13: 602-8. (Among 11 cases of liver injury from anti-TNF agents identified over a 5 year period in Iceland, 9 were due to infliximab [among 1076 patients treated=1:120], 1 adalimumab [270 treated] and 1 etanercept [430 treated]; 8 women, 3 men; latency 1 to 6 months; 5 were jaundiced [peak bilirubin 0.6-7.6 mg/dL, ALT 169-1658 U/L, Alk P 71-916 U/L], 8 hepatocellular, 2 cholestatic and 1 mixed injury; 8 had ANA, 5 were treated with corticosteroids [only 1 long term], 8 were switched to another anti-TNF agent without recurrence). 25131534
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases [0.7%] were attributed to a tumor necrosis factor antagonist, including 3 to infliximab, 2 etanercept and 1 adalimumab, but none to certolizumab or golimumab). 25754159
Chiu YM, Tang CH, Hung ST, Yang YW, Fang CH, Lin HY. A real-world risk analysis of biological treatment (adalimumab and etanercept) in a country with a high prevalence of tuberculosis and chronic liver disease: a nationwide population-based study. Scand J Rheumatol 2017:46:236-40. 27766916 (Nationwide population-based data on use of adalimumab [n=4049] and etanercept [n=5117] between 2007 and 2011, identified higher rates of serious hepatic events for adalimumab vs etanercept [0.75 vs 0.39 per 100 person years] as well as higher rates of tuberculosis [1.62 vs 0.57 per 100 person-years]).
Koller T, Galambosova M, Filakovska S, Kubincova M, Hlavaty T, Toth J, Krajcovicova A, et al. Drug-induced liver injury in inflammatory bowel disease: 1-year prospective observational study. World J Gastroenterol. 2017;23:4102-4111. (Among 251 patients with inflammatory bowel disease enrolled in a prospective study with liver test monitoring every 3 months, 66 [22%] had ALT elevations that were usually transient and mild, and of 33 patients on adalimumab, only 2 had elevations above twice normal, none of which were persistent and none had elevations above 3 times normal). 28652663
Kok B, Lester ELW, Lee WM, Hanje AJ, Stravitz RT, Girgis S, Patel V, et al; United States Acute Liver Failure Study Group. Acute liver failure from tumor necrosis factor-α antagonists: report of four cases and literature review. Dig Dis Sci. 2018;63:1654-1666. (Among more than 2500 cases of acute liver failure enrolled in a prospective US database between 1998 and 2014, 4 were attributed to infliximab induced liver injury, but none were attributed to adalimumab or other TNF antagonists). 29564668
Drugs for psoriatic arthritis. Med Lett Drugs Ther. 2019;61(1588):203-210. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriatic arthritis, mentions that five TNF antagonists are approved for this condition and appear to have similar efficacy and their adverse events include reactivation of hepatitis B; does not mention the risk of hepatotoxicity). 31999665
Bruno CD, Fremd B, Church RJ, Daly AK, Aithal GP, Björnsson ES, Larrey D, et al. HLA associations with infliximab-induced liver injury. Pharmacogenomics J. 2020;20:681-686. (Amng 16 European patients with infliximab-induced liver injury compared to 60 matched controls, genome-wide association studies showed no apparent gene differences but imputation of HLA alleles found a higher carrier rate of B*39:01 in cases [n=4, carrier rate 25%] vs controls [none, predicted estimate 2%). 32024945
Drugs for rheumatoid arthritis. Med Lett Drugs Ther. 2021;63(1637):177-184. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for rheumatoid arthritis, mentions that five TNF antagonists are indicated for rheumatoid arthritis if maximal tolerated doses of methotrexate are not adequately effective; description of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but not hepatotoxicity). 35085210
Björnsson HK, Gudbjornsson B, Björnsson ES. Infliximab-induced liver injury: clinical phenotypes, autoimmunity and the role of corticosteroid treatment. J Hepatol. 2022;76:86-92. (Among 36 Icelandic patients who developed elevated enzymes after starting infliximab therapy between 2009 and 2020, median age was 46 years, 78% were women, only 4 with jaundice, 2 hospitalized, 67% with ANA [half were positive before therapy], infliximab stopped in all but ALT elevations frequently persisted, 17 [47%] were treated with corticosteroids which led to rapid resolution [45 vs 79 days without corticosteroids], and all eventually stopped corticosteroid without relapse even when treated with other TNF antagonists). 34487751
Núñez F P, Quera R, Bay C, Castro F, Mezzano G. Drug-induced liver injury used in the treatment of inflammatory bowel disease. J Crohns Colitis. 2022;16:1168-1176. (Review of the hepatic adverse events that occur with therapies of inflammatory bowel disease such as sulfasalazine, thiopurines, methotrexate, TNF antagonists, newer monoclonal and small molecule inhibitors, and sphingosine-1-phosphate modulators). 35044449
Akyol L, Balcı MA. Influence of anti-TNF-α treatment on liver and kidney functions in patients with ankylosing spondylitis: a retrospective longitudinal study. Eur J Rheumatol. 2022;9:31-35. (Among 148 patients with ankylosing spondylitis treated with TNF antagonists [golimumab 68, certolizumab 33, etanercept 23, adalimumab 18 and infliximab 1] for at least one year, mean ALT and AST levels remained within the normal range). 34101575
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%] atorvastatin [8%], nivolumab/ipilimumab [8%], infliximab [5%], nitrofurantoin [4.5%], disulfiram [2%], ibuprofen [2%], and HDS products [7.3%]; adalimumab and other TNF antagonists not mentioned). 35899490
Drugs for inflammatory bowel disease. Med Lett Drugs Ther. 2023;65(1680):105-112. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for ulcerative colitis and Crohn disease, mentions that the monoclonal antibodies to TNF are effective in induction and maintenance of remissions, infliximab and adalimumab being approved for both forms, certolizumab for ulcerative colitis only and golimumab for Crohn disease only; discussion of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but without mention of hepatotoxicity). 37418329
Drugs for plaque psoriasis. Med Lett Drugs Ther. 2024;66(1712):153-160. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriasis, mentions that four TNF antagonists are approved for moderate-to-severe plaque psoriasis and that adverse events include reactivation of hepatitis B but does not mention hepatotoxicity). 39302348
Björnsson HK, Sigmundsson HK, Björnsson ES. Severe liver injury due to infliximab therapy and adalimumab. Scand J Gastroenterol. 2025;60:1238-1246. (Review of the literature identified 12 reports of severe acute liver injury due to infliximab but only one due to adalimumab [Hagel 2011] in a patient who ultimately recovered). 41086316
Bessone F, Bjornsson ES. Autoimmune-like hepatitis induced by drugs: Still many unanswered questions. World J Hepatol. 2025;17:110946. (Review of the clinical features, causes, diagnosis, and management of drug-induced autoimmune-like hepatitis and comparison to spontaneous autoimmune hepatitis mentions the most common causes as minocycline, nitrofurantoin, hydralazine, methyldopa, infliximab, adalimumab, statins, interferon, and imatinib). 41368109
Algarzae NK, Alotaibi HM, Alajlan AH, AlSaleh MR, Alsalman AA. Hepatotoxicity induced by adalimumab in chronic plaque psoriasis patient: a case report. Int Med Case Rep J. 2025;18:877-881. (24 year old woman with psoriasis developed abnormal liver tests 6 months after starting adalimumab [bilirubin 1.2 mg/dL, ALT 152 U/L, Alk P not provided) which fell into the normal range within 6 weeks of stopping, later tolerating Risankizumab [IL-23 inhibitor]). 40662078
Caballero-Linares CF, Cei B, Alfageme F. Hepatotoxicity associated with adalimumab in hidradenitis suppurativa: a report of two cases of drug-induced liver injury. Dermatol Pract Concept. 2025;15:5320. (Two women, ages 47 and 56 years, with hidradenitis suppurative developed liver test abnormalities the first after receiving adalimumab for 4 years [laboratory data not given] and the second after 3 days of an initial dose [ALT 1595 U/L, GGT 556 U/L, bilirubin not provided] both resolving after discontinuation). 40790407
Abdulhameed NM, Banama M, Alsayed AlMarzooqi E. Adalimumab-induced hepatocellular injury in a young male with hidradenitis suppurativa and underlying metabolically dysfunctional liver disease: a case report. Cureus. 2025;17:e100354. (20 year old man with hidradenitis suppurativa developed gradually rising ALT levels after starting adalimumab [ALT 40 to 67 to 139 U/L], ultrasound demonstrating probable steatosis said to be due to the combination of nonalcoholic steatohepatitis and adalimumab induced liver injury but no follow up provided). 41613664
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 1 was attributed to infliximab and none to adalimumab). 38992407
Kuo MH, Tseng CW, Tseng KC, Lu MC, Tung CH, Chen NT, Huang KY, et al. The relationship between TNF-α inhibitor potency and HBV reactivation in patients with rheumatic disorders. Liver Int. 2025;45:e70152.. (Among 72 HBsAg positive patients treated with anti-TNF without prophylaxis, 21 [29%] developed reactivation vs 2 of 39 [5%] with prophylaxis, and 28 of 600 [5%] with anti-HBc without HBsAg and without prophylaxis, reactivation being more frequent with adalimumab that with etanercept or golimumab). 40418092
Chen H, Jiang S, Wang J, Zhang A, Zhu L. Hepatobiliary disorders associated with TNF-α inhibitors: a pharmacovigilance analysis of FAERS and JADER. Front Immunol. 2026;16:1739631. (Analysis of the US FDA adverse event reporting system [FAERS] between 2004 and 2025 for TNF antagonists found 19,083 reports of hepatobiliary events, 9501 for adalimumab, 3979 infliximab, 3949 etanercept, 1012 certolizumab pegol, and 642 golimumab). 41601665

## OTHER REFERENCE LINKS

1. Recent References on Adalimumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Adalimumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Adalimumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Adalimumab)